# Eribulin

## OVERVIEW

### Introduction

Eribulin mesylate is an inhibitor of microtubule function and is used as an antineoplastic agent for refractory, metastatic breast cancer and liposarcoma. Despite its cytotoxic activity against cancer cells, eribulin has rarely been implicated in causing clinically apparent acute liver injury.

### Background

Eribulin (er' i bue' lin) is a synthetic macrocyclic analogue of halichondrin B, a naturally occurring inhibitor of mitotic division found in a species of marine sponges (Halichondria okadai). Eribulin binds to the growing ends of microtubules preventing cell division (mitotic arrest) which leads to tubulin sequestration in aggregates and apoptotic cell death. Eribulin was approved for use in cancer chemotherapy in 2010 and current indications are for metastatic breast cancer after failure of chemotherapy with an anthracycline and taxane. It is also approved for use in metastatic, refractory liposarcoma. Eribulin is given intravenously in doses of 1.4 mg/m^2^, typically on days 1 and 8 of 21 day cycles. Eribulin is available in single use vials of 1 mg per 2 mL under the trade name Halaven. Side effects are common and include nausea, vomiting, fatigue, headache, dizziness, peripheral neuropathy, hoarseness, ataxia, dysphagia, urinary retention, constipation, diarrhea, bone marrow suppression, alopecia and phlebitis at the infusion site. Rare, but potentially severe adverse events include severe neutropenia, peripheral neuropathy, prolongation of the QTc interval and embryo-fetal toxicity.

### Hepatotoxicity

Eribulin is a cytotoxic chemotherapeutic agent and serum aminotransferase and alkaline phosphatase elevations are common during cyclic therapy of breast cancer and liposarcoma. The reported rates of ALT elevations have ranged from 8% to 83% with values above 5 times the upper limit or normal (ULN) in 2% to 5%. Isolated mention of “toxic hepatitis” have been made in reports of clinical trials of eribulin but no details of the onset, clinical features and course have been published and the role of eribulin in these outcomes is uncertain. Nevertheless, despite high rates of serum enzyme elevations during treatment, cases of clinically apparent liver injury have not been reported in detail and must be rare.

Likelihood score: E* (unproven but suspected cause of liver injury).

### Mechanism of Injury

Eribulin causes mitotic arrest in rapidly dividing cells and likely causes similar changes in some hepatocytes, perhaps accounting for the frequent occurrence of mild serum aminotransferase elevations during therapy. Eribulin undergoes minimal hepatic metabolism and is mostly excreted unchanged. It also has little or no effect on drug metabolism and minimal drug-drug interactions.

### Outcome and Management

Serum enzyme elevations are frequent during cancer chemotherapy with eribulin, but are rarely dose limiting. Serum aminotransferase elevations above 5 times ULN should lead to dose interuption or modification. Serum ALT or AST elevations above ten times ULN or any elevations accompanied by symptoms of liver disease or jaundice should lead to discontinuation of eribulin therapy, but should also trigger a search for other causes.

Drug Class: Antineoplastic Agents, Miscellaneous, Microtubule Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Eribulin – Halaven®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Eribulin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Eribulin | 253128-41-5 | C40-H59-N-O11 | Eribulin chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 20 February 2018

Zimmerman HJ. The vinca alkaloids. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 692-4. (Expert review of hepatotoxicity published in 1999 before the availability of eribulin, which is not discussed).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 549-68. (Review of hepatotoxicity of published in 2013; eribulin is not discussed).
Chabner BA, Bertino J, Clearly J, Ortiz T, Lane A, Supko JG, Ryan DP. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1677-1730. (Textbook of pharmacology and therapeutics).
Cortes J, Vahdat L, Blum JL, Twelves C, Campone M, Roché H, Bachelot T, et al. Phase II study of the halichondrin B analog eribulin mesylate in patients with locally advanced or metastatic breast cancer previously treated with an anthracycline, a taxane, and capecitabine. J Clin Oncol 2010; 28: 3922-8. (Among 291 patients with refractory metastatic breast cancer treated with eribulin, the objective response rate was 9% and toxicity was “manageable”, side effects included fatigue [65%], neutropenia [60%], alopecia [60%], neuropathy [33%]; no mention of ALT elevations or hepatotoxicity). 20679609
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 2 to antineoplastic agents [melphalan and gemtuzumab], but none to eribulin). 20949552
Cortes J, O'Shaughnessy J, Loesch D, Blum JL, Vahdat LT, Petrakova K, Chollet P, et al.; EMBRACE (Eisai Metastatic Breast Cancer Study Assessing Physician's Choice Versus E7389) investigators. Eribulin monotherapy versus treatment of physician's choice in patients with metastatic breast cancer (EMBRACE): a phase 3 open-label randomized study. Lancet 2011; 377 (9769): 914-23. (Among 762 women with metastatic breast cancer treated with eribulin or standard therapy, overall survival was improved with eribulin [13.1 vs 10.6 months] and adverse events were similar, although neutropenia and neuropathy were more frequent with eribulin; no mention of ALT elevations or hepatotoxicity). 21376385
Schöffski P, Ray-Coquard IL, Cioffi A, Bui NB, Bauer S, Hartmann JT, Krarup-Hansen A, et al.; European Organisation for Research and Treatment of Cancer (EORTC) Soft Tissue and Bone Sarcoma Group (STBSG). Activity of eribulin mesylate in patients with soft-tissue sarcoma: a phase 2 study in four independent histological subtypes. Lancet Oncol 2011; 12: 1045-52. (Among 128 patients with soft tissue sarcomas treated with eribulin, common severe side effects included neutropenia [52%], anemia [7%] and ALT elevations [57%], which were above 5 times ULN in 6 patients [5%], but none developed clinically apparent liver injury). 21937277
Eribulin mesylate (Halaven) for breast cancer. Med Lett Drugs Ther 2011; 53 (1362): 30-1. (Concise review of the mechanism of action, efficacy, safety and costs of eribulin shortly after its approval for use in the US, mentions that adverse events include neutropenia, anemia, fatigue, neuropathy, nausea and constipation; no mention of ALT elevations or hepatotoxicity). 21502935
Aogi K, Iwata H, Masuda N, Mukai H, Yoshida M, Rai Y, Taguchi K, et al. A phase II study of eribulin in Japanese patients with heavily pretreated metastatic breast cancer. Ann Oncol 2012; 23: 1441-8. (Among 80 Japanese women with refractory metastatic breast cancer treated with eribulin, the objective response rate was 21% and common side effects were neutropenia [98%], alopecia [58%], fatigue [46%], neuropathy [23%], ALT elevations [33%: 4% were greater than 5 times ULN] and Alk P elevations [21%]). 21989327
de Bono JS, Molife LR, Sonpavde G, Maroto JP, Calvo E, Cartwright TH, Loesch DM, et al. Phase II study of eribulin mesylate (E7389) in patients with metastatic castration-resistant prostate cancer stratified by prior taxane therapy. Ann Oncol 2012; 23: 1241-9. (Among 108 men with refractory metastatic prostate cancer treated with eribulin, common side effects were neutropenia, fatigue and peripheral neuropathy; no mention of ALT elevations or hepatotoxicity). 21903605
Wilks S, Puhalla S, O'Shaughnessy J, Schwartzberg L, Berrak E, Song J, Cox D, Vahdat L. Phase 2, multicenter, single-arm study of eribulin mesylate with trastuzumab as first-line therapy for locally recurrent or metastatic HER2-positive breast cancer. Clin Breast Cancer 2014; 14: 405-12. (Among 52 patients with metastatic breast cancer treated with the combination of eribulin and trastuzumab, the objective response rate was 71% and ALT elevations above 5 times ULN occurred in only one patient [2%]). 25024001
McIntyre K, O'Shaughnessy J, Schwartzberg L, Glück S, Berrak E, Song JX, Cox D, et al. Phase 2 study of eribulin mesylate as first-line therapy for locally recurrent or metastatic human epidermal growth factor receptor 2-negative breast cancer. Breast Cancer Res Treat 2014; 146: 321-8. (Among 56 women with recurrent or metastatic breast cancer treated with eribulin, the objective response rate was 29% and side effects were common, including fatigue, neutropenia and neuropathy; no mention of ALT elevations or hepatotoxicity). 24699910
Kaufman PA, Awada A, Twelves C, Yelle L, Perez EA, Velikova G, Olivo MS, et al. Phase III open-label randomized study of eribulin mesylate versus capecitabine in patients with locally advanced or metastatic breast cancer previously treated with an anthracycline and a taxane. J Clin Oncol 2015; 33: 594-601. (Among 1102 women with previously treated metastatic breast cancer treated with eribulin or capecitabine, the objective response rate was similar in the 2 groups, but the duration of response was longer with capecitabine; ALT elevations occurred in 8.5% vs 4.2% and were above 5 times ULN in 3.3% vs 0.5%; one patient treated with eribulin died of “toxic hepatitis”). 25605862
Goodin S, Barbour S, Song J, Berrak E, Cox D. Safety and tolerability of eribulin mesylate in patients with pretreated metastatic breast cancer. Am J Health Syst Pharm 2015; 72: 2150-6. (Pooled analysis of results from 3 phase II and 1 phase III trial of eribulin in women with previously treated, metastatic breast cancer found that ALT elevations arose in 5% of patients, but none [that were attributable to eribulin] were above 5 times ULN). 26637514
Garrone O, Montemurro F, Saggia C, La Verde N, Vandone AM, Airoldi M, De Conciliis E, et al. Eribulin in pretreated metastatic breast cancer patients: results of the TROTTER trial-a multicenter retrospective study of eribulin in real life. Springerplus 2016; 5: 59. (Among 113 Italian “real life” women with metastatic breast cancer treated with eribulin, the objective response rate was 24% and toxicity was “manageable”; liver test abnormalities occurred in 18 [16%] and were above 5 times ULN in 2 [2%]). 26835238
Takashima T, Tokunaga S, Tei S, Nishimura S, Kawajiri H, Kashiwagi S, Yamagata S, et al. A phase II, multicenter, single-arm trial of eribulin as first-line chemotherapy for HER2-negative locally advanced or metastatic breast cancer. Springerplus 2016; 5: 164. (Among 35 Japanese women with metastatic breast cancer treated with eribulin as a first line therapy, the objective response rate was 54% and adverse events were “acceptable”; ALT and AST elevations occurred in 29 patients [83%], but were above 5 times ULN in only one [3%]). 27026861
Kobayashi T, Tomomatsu J, Fukada I, Shibayama T, Teruya N, Ito Y, Iwase T, et al. Eribulin-induced liver dysfunction as a prognostic indicator of survival of metastatic breast cancer patients: a retrospective study. BMC Cancer 2016; 16: 404. . (Among 151 women with metastatic breast cancer treated with eribulin between 2011 and 2013, 42 [28%] developed ALT or AST elevations above 3 times ULN after a median time of 21 days, these elevations leading to dose interruption or modification in 10 and permanent discontinuation in 1 patient; nevertheless, women with such enzyme elevations had a better overall and progression free survival). 27389013
Bunchorntavakul C, Reddy KR. Drug hepatotoxicity: newer qgents. Clin Liver Dis 2017; 21: 115-34. . (Review of the hepatotoxicity of recently approved medications including tryosine kinase receptor inhibitors and monoclonal antibodies does not specifically discuss eribulin). 27842767

## OTHER REFERENCE LINKS

1. Recent References on Eribulin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Eribulin/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2. Trials on Eribulin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Eribulin)